# Nerandomilast

## OVERVIEW

### Introduction

Nerandomilast is a recently approved oral inhibitor of phosphodiesterase 4B (PDE4B) used to slow the loss of lung function in adults with idiopathic pulmonary fibrosis and progressive pulmonary fibrosis. Nerandomilast has not been associated with serum aminotransferase elevations during therapy or with clinically apparent liver injury.

### Background

Nerandomilast (ner” an doe’ mi last) is a small molecule inhibitor of phosphodiesterase 4B (PDE4B), an enzyme that degrades cyclic adenosine monophosphate (cAMP), a messenger molecule involved in modulating inflammation and fibrosis. By blocking its breakdown, nerandomilast raises intracellular cAMP which has anti-inflammatory and antifibrotic effects in the lung. In two large pre-registration, placebo-controlled trials, nerandomilast was shown to slow the progression of pulmonary dysfunction in adults with idiopathic pulmonary fibrosis and progressive pulmonary fibrosis, given alone or with another antifibrotic agent (nintedanib or pirfenidone). It was approved in the United States in 2025, first for idiopathic pulmonary fibrosis and shortly afterward for progressive pulmonary fibrosis. Nerandomilast is available in tablets of 9 and 18 mg under the brand name Jascayd. The usual adult dose is 18 mg orally twice daily which can be decreased in patients who cannot tolerate the higher dose or who are taking a strong CYP3A inhibitor. Common side effects include diarrhea, upper respiratory tract infection, decreased appetite, weight loss, nausea and vomiting, fatigue, headache, back pain, dizziness, and depression. Diarrhea is the most frequent and the most common reason for discontinuation. Nerandomilast has not been associated with a specific severe adverse event, and the product label contains no boxed warning and no warnings and precautions section. Nerandomilast may have embryo-fetal toxicity based upon studies in laboratory animals.

### Hepatotoxicity

In the two large pre-registration trials of nerandomilast in idiopathic and progressive pulmonary fibrosis (each enrolling roughly 1,180 patients treated for at least 52 weeks with 9 or 18 mg twice daily or placebo), serum aminotransferase elevations were not identified as a notable adverse event, and hepatic adverse reactions did not appear among the events reported more often with nerandomilast than with placebo. Serum ALT elevations above 3 times the upper limit of normal (ULN) arose in 0% to 1.5% of both the nerandomilast- and placebo-treated subjects, and there were no instances of clinically apparent liver injury attributable to nerandomilast. The product label does not list hepatic laboratory abnormalities among the adverse reactions, gives no recommendation for routine liver test monitoring, and requires no dose adjustment for mild or moderate hepatic impairment. Since its approval, there have been no published reports of liver injury attributed to nerandomilast, but clinical experience with the drug has been limited.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The absence of hepatic injury from nerandomilast is not fully explained. Nerandomilast is metabolized in the liver, primarily by CYP 3A4, so that a toxic or immunogenic intermediate of its metabolism could in theory cause liver injury, but none has been demonstrated. Its exposure is not meaningfully altered by mild or moderate hepatic impairment. Nerandomilast has not been studied in patients with severe hepatic impairment but is not recommended in that setting.

### Outcome and Management

Nerandomilast has not been linked to serum aminotransferase elevations during therapy or to instances of clinically apparent liver injury, and no specific monitoring or management for hepatotoxicity is recommended. Therapy should be at least temporarily discontinued if clinically apparent liver injury with symptoms or jaundice arises during treatment and held until another cause is identified.

Drug Class: Antifibrotic Agents

Other Drugs in the Subclass: Nintedanib; Pirfenidone

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Nerandomilast – Jascayd®

DRUG CLASS

Antifibrotic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Nerandomilast)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Nerandomilast | 1423719-30-5 | C20H25ClN6O2S | CID: 166177189

## ANNOTATED BIBLIOGRAPHY

References updated: 19 September 2026

Abbreviations used: ULN, upper limit of normal; FVC, forced vital capacity; IPF, idiopathic pulmonary fibrosis; PPF, progressive pulmonary fibrosis.

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Expert review of drug induced liver injury published in 1999, before the availability of nerandomilast and other antifibrotic agents).
Drugs@FDA. 2025. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2025/218764Orig1s000IntegratedR.pdf (FDA website with the product label and integrated review of efficacy and safety of nerandomilast based upon data submitted by the sponsor in support of its approval for idiopathic pulmonary fibrosis, mentions that ALT elevations above 3 times ULN are rare, occur at a similar rate as placebo treatment [0% to 1.5%], and are usually transient and unrelated to nerandomilast therapy which is often used in conjunction with other antifibrotic medications which have been linked to liver injury).
Richeldi L, Azuma A, Cottin V, Kreuter M, Maher TM, Martinez FJ, Oldham JM, et al.; FIBRONEER-IPF Trial Investigators. Nerandomilast in patients with idiopathic pulmonary fibrosis. N Engl J Med. 2025;392:2193-2202. (Among 1,177 patients with idiopathic pulmonary fibrosis treated for 52 weeks with nerandomilast [9 or 18 mg twice daily] vs placebo, mostly on background antifibrotic therapy, the change in forced vital capacity was -139 mL and -115 mL vs -184 mL, while the most frequent adverse event was diarrhea [31% and 41% vs 16%], serious adverse events occurred in 31% and 30% vs 33%, none of which were hepatic, although “suspected” drug-induced liver injury arose in 5.1% and 4.1% vs 5.3%; no mention of ALT elevations). 40387033
Maher TM, Assassi S, Azuma A, Cottin V, Hoffmann-Vold AM, Kreuter M, Oldham JM, et al.; FIBRONEER-ILD Trial Investigators. Nerandomilast in patients with progressive pulmonary fibrosis. N Engl J Med. 2025;392:2203-2214. (Among 1,176 patients with progressive pulmonary fibrosis treated for 52 weeks with nerandomilast [9 or 18 mg twice daily] vs placebo, with or without background nintedanib, the change in forced vital capacity was -85 mL and -99 mL vs -166 mL, while the most common adverse event was diarrhea [30% and 37% vs 25%], serious adverse events occurred in 32% and 33% vs 35%, and “potential” drug-induced liver injury arose in 5.6% and 6.6% vs 4.9%; no mention of ALT elevations). 40388329

## OTHER REFERENCE LINKS

1. Recent References on Nerandomilast: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&term=Nerandomilast+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice%2FCI+OR+bile+duct+diseases%2FCI+OR+liver%2FDE+OR+liver+diseases%2FCI))

2. Trials on Nerandomilast: from ClinicalTrials.gov (https://clinicaltrials.gov/search?term=Nerandomilast)